# Amlodipine

## OVERVIEW

### Introduction

Amlodipine besylate is a second generation calcium channel blocker that is used in the therapy of hypertension and angina pectoris. Amlodipine has been linked to a low rate of serum enzyme elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Amlodipine (am loe' di peen) belongs to the dihydropyridine class of calcium channel blockers and is used in the treatment of both hypertension and angina pectoris. Like other calcium channel blockers, amlodipine acts by blocking the influx of calcium ions into vascular smooth muscle and cardiac muscle cells during membrane depolarization. This action causes relaxation of vascular and arterial smooth muscle cells, resulting in arterial vasodilation and a decrease in cardiac work and oxygen consumption. Amlodipine was approved in the United States in 1992 and it remains in wide use, with several million prescriptions filled yearly. Current indications include hypertension and coronary artery disease (angina pectoris). Amlodipine is available generically and under the brand name of Norvasc. Tablet strengths include 2.5, 5, and 10 mg. The recommended dose in adults is 2.5 to 10 mg once daily, usually starting with the lowest dose. Chronic therapy is typical. Recently, multiple fixed dose combinations of amlodipine with other agents have become available including amlodipine (5 or 10 mg) with aliskiren (150 or 300 mg: Tekamlo), aliskiren with hydrochlorothiazide (12.5 and 25 mg: Amturnide), atorvastatin (10, 20, 40 or 80 mg: Caduet and generic), benzapril (10, 20 or 40 mg: Lotrel, Amlobenz, and generic), benzapril and hydrochlorothiazide (12.5 and 25 mg: Tribenzor), olmesaran (20 and 40 mg: Azor), and telmisartan (40 or 80 mg: Twynsta), valsartan (160 and 320 mg: Exforge) and valsartan with hydrochlorothiazide (25 mg: Exforge HCT). Like most calcium channel blockers, amlodipine is generally well tolerated. Side effects are largely due to the vasodilating activities and can include headache, flushing, dizziness, fatigue, nausea, diarrhea, palpitations, peripheral edema and rash.

### Hepatotoxicity

Chronic therapy with amlodipine is associated with a low rate of serum enzyme elevations at rates that are similar to matched control populations. The enzyme elevations are usually mild, transient and asymptomatic and may resolve even during continued therapy. Clinically apparent liver injury from amlodipine is rare and described only in isolated case reports. In the few idiosyncratic cases reported, the latency period to onset of liver injury was usually 4 to 12 weeks, but examples with prolonged latency have also been published (10 months and several years). The latency period is shorter with recurrence on reexposure, including several instances of recurrence after liver injury due to other calcium channel blockers. The pattern of serum enzyme elevations is usually mixed or cholestatic. Rash, fever and eosinophilia have not been described and autoantibodies are not typical.

Likelihood score: C (probable but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of amlodipine hepatotoxicity is not known, but liver injury is probably due to production of a toxic intermediate in its metabolism.

### Outcome and Management

The severity of liver injury from amlodipine ranges from mild and transient serum enzyme elevations to self-limited jaundice. Complete recovery is expected after stopping the drug and recovery is usually rapid (4 to 8 weeks). Cases with chronic or fulminant liver injury due to amlodipine have not been reported. Little information is available on recurrence with rechallenge but there may be some degree of cross-sensitivity to hepatotoxicity with other calcium channel blockers.

Drug Class: Cardiovascular Agents, Calcium Channel Blockers

Other Drugs in the Subclass, Calcium Channel Blockers: Diltiazem, Felodipine, Isradipine, Nicardipine, Nifedipine, Nimodipine, Nisoldipine, Verapamil

## CASE REPORT

### Case 1. Acute hepatitis-like syndrome attributed to amlopidine.

[Modified from: Basile C, Mascia E. Dihydropyridine calcium channel blockers: a rare and reversible cause of hepatotoxicity with cholestasis in a CAPD patient. Nephrol Dial Transplant 1999; 14: 2776-7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/10534534)]

A 76 year old man with diabetes and end-stage renal disease developed jaundice while on long term nifedipine therapy (60 mg daily for ~3 years) for hypertension. He was taking insulin, but no other medications. He had no risk factors for viral hepatitis and did not drink alcohol. Serum bilirubin was 2.5 mg/dL and rose over the next few months to 6.2 mg/dL. Tests for acute hepatitis A, B and C were negative and abdominal ultrasonography showed a normal liver and gallbladder. Nifedipine was stopped and he recovered rapidly. Several months later, amlodipine was started (10 mg daily) and within 6 weeks, he developed jaundice and a cholestatic pattern of serum enzyme elevations. Once amlodipine was stopped, liver tests improved and were normal three weeks later.

#### Key Points

Medication: | Nifedipine (60 mg daily) and then amlodipine (10 mg daily)
Pattern: | Cholestatic (R=0.3 and 0.8 during recurrence)
Severity: | 2+ (jaundiced, but not hospitalized for liver injury)
Latency: | 3 years for nifedipine, 2 months for amlodipine
Recovery: | 3 to 4 weeks
Other medications: | Insulin

#### Laboratory Values

Date | Duration Therapy | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Long term therapy with nifedipine (60 mg daily)
May 12, 1998 | 3 years | | 13 | 144 | 0.3
Sep 9, 1998 | | | 47 | 783 | 0.5
Dec 9, 1998 | | | 40 | 955 | 2.5
Jan 11, 1999 | 3.5 years | 0 | 79 | ... | 6.2
Nifepidine stopped January 11, 1999
Jan 16, 1999 | | 1 week | 46 | 531 | 4.0
Jan 23, 1999 | | 2 weeks | 45 | 419 | 1.8
Feb 11, 1999 | | 4 weeks | 17 | 185 | 0.9
Amlodipine (10 mg daily) started in late March, 1999
Apr 10, 1999 | 2 weeks | | 43 | 398 | 0.6
May 5, 1999 | 6 weeks | 0 | 74 | 398 | 6.3
Amlodipine stopped May 7, 1999
May 11, 1999 | | 4 days | 70 | 399 | 5.4
May 13, 1999 | | 6 days | 54 | 314 | 4.1
May 28, 1999 | | 3 weeks | 19 | 181 | 1.3
Normal Values | | | <55 | <250 | <1.2

#### Comment

One of the few reports of acute liver injury with jaundice attributed to calcium channel blockers. The patient initially developed a cholestatic hepatitis while on long term nifepidine therapy. Liver tests because steadily worse and nifepidine was ultimately withdrawn, whereupon liver tests fell to normal within 4 weeks. There was a recurrence of liver injury within 2 to 6 weeks of restarting another calcium channel blocker with a similar pattern of liver test abnormalities and a similar rapid improvement upon stopping. Both nifedipine and amlodipine are dihydropyridines, but there structures are dissimilar.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amlodipine – Generic, Norvasc®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=amlodipine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Amlodipine | 88150-42-9 | C20-H25-C1-N2-O5 | Amlodipine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 March 2016

Zimmerman HJ. Calcium channel blockers. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 646-7. (Expert review of hepatotoxicity published in 1999; among calcium channel blockers, diltiazem, nifedipine, bepridil and verapamil have been incriminated in instances of hepatic injury; amlodipine is not mentioned).
De Marzio DH, Navarro VJ. Calcium channel blockers. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of calcium channel blockers; diliazem and verapamil have been implicated in causing cholestatic liver injury in a small number of patients; amlodipine is not specifically mentioned).
Michel T, Hoffman BB. Calcium channel antagonists. Treatment of myocardial ischemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 755-60. (Textbook of pharmacology and therapeutics).
Osterloh I. The safety of amlodipine. Am Heart J 1989; 118:1114-9. (Analysis of adverse events in a pooled database of 2495 patients treated with amlodipine and ~1800 controls reported similar rate of ALT elevations with amlodipine [4.3%] as with hydrochlorthiazine [6.3%], and no serious liver toxicity). 2573265
de Luis DA, Aller R, Moreira V. Hepatic toxicity and amlodipine. Med Clin (Barcelona). 1998; 110: 638-9 [Spanish]. (66 year old man developed serum enzyme elevations 3 months after starting amlodipine [bilirubin normal, ALT 211 U/L, Alk P 369 U/L], resolving within 2 months of stopping). 9656204
Basile C, Mascia E. Dihydropyridine calcium channel blockers: a rare and reversible cause of hepatotoxicity with cholestasis in a CAPD patient. Nephrol Dial Transplant 1999; 14: 2776-7. (76 year old man developed jaundice 3 years after starting nifedipine [bilirubin 6.2 mg/dL, ALT 79 U/L, Alk P 955 U/L], resolving within 1 month of stopping and recurring within 6 weeks of starting amlodipine [bilirubin 6.3 mg/dL, ALT 74 U/L, Alk P 398 U/L], resolving in 3 weeks: Case 1). 10534534
Lafuente NG. Calcium channel blockers and hepatotoxicity. Am J Gastroenterol 2000; 95: 2145. (69 year old developed jaundice 10 months after starting amlodipine [bilirubin 4.0 mg/dL, ALT 256 U/L, Alk P 344 U/L]; subsequent switching to diltiazem caused a similar pattern of injury after 5 months [bilirubin 3.3 mg/dL, ALT 355 U/L, Alk P 415 U/L], resolving in several weeks of stopping). 10950093
Khemissa-Akouz F, Ouguergouz F, Sulem P, Tkoub el M, Vaucher E. Amlodipine-induced acute hepatitis. Gastroenterol Clin Biol 2002; 26: 637-8. French. (77 year old man developed jaundice one month after starting amlopidine [bilirubin 7.4 mg/dL, ALT 30 times ULN, Alk P 2 times ULN, ANA positive], resolving within 8 weeks of stopping). 12193867
Lopez Vivancos J, Bara Olivan B, Muniz Garcia R. [Toxic hepatitis caused by amlodipine] Gastroenterol Hepatol 2002; 25: 112. Spanish. (66 year old man developed asymptomatic enzyme elevations 2 months after starting amlodipine [bilirubin normal, ALT 267 rising to 694 U/L, Alk P 367 U/L], resolving within 3 months of stopping). 11841767
Zinsser P, Meyer-Wyss B, Rich P. Hepatotoxicity induced by celecoxib and amlodipine. Swiss Med Wkly 2004; 134:201. (87 year old woman developed jaundice and pruritus after several years of amlodipine therapy [bilirubin 20.8 mg/dL, ALT 300 U/L, Alk P 1019 U/L]; after withdrawal she began to recover, but then developed urosepsis and died 3 weeks after presentation). 15106034
ALLHAT. Major outcomes in high-risk hypertensive patients randomized to angiotensin-converting enzyme inhibitor or calcium channel blocker vs diuretic: the Antihypertensive and Lipid-Lowering Treatment to Prevent Heart Attack Trial (ALLHAT). JAMA 2002; 288:2981-97. (Large controlled trial of antihypertensive agents including amlodipine which included 33,357 participants; no mention of ALT elevations or liver related adverse events). 12479763
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a calcium channel blocker). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; only one case was possibly linked to a calcium channel blocker--felodipine). 16165719
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, calcium channel blockers were implicated as a sole agent in 2 cases [1 amlodipine, 1 verapamil] and as one of several agents in 2 cases [both amlodipine]). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to a calcium channel blocker). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 ; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but amlodipine was not implicated in any case, despite being among the top 10 most commonly prescribed drugs in Iceland). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none were linked to amlodipine or other calcium channel blockers). 24552865
Demirci H, Polat Z, Kantarcioglu M, Kekilli M, Uygun A, Bagci S. Short-term amlodipine induced liver injury : an extremely rare acute complication. Acta Gastroenterol Belg 2013; 76 (4): 441. (46 year old man was found to have abnormal liver tests one week after switching from ramipril to amlodipine [bilirubin 1.4 mg/dL, ALT 923 U/L, Alk P 102 U/L, INR 1.02], resolving within 3 weeks of stopping). 24592551
Hammerstrom AE. Possible amlodipine-induced hepatotoxicity after stem cell transplant. Ann Pharmacother 2015; 49: 135-9. (34 year old man with leukemia and graft-vs-host disease after hematopoietic cell transplant developed ALT and AST elevations without jaundice a few days after starting high doses of methylprednisolone and amlodipine [for hypertension], values improving wihtin two weeks of stopping amlodipine and decreasing the dose of corticosteroids). 25239629
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, amlodipine was implicated as probable in one case and as definite or highly likely in none). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Amlodipine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=amlodipine/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Amlodipine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=amlodipine)